# Cetirizine

## OVERVIEW

### Introduction

Cetirizine and its enantiomer levocetirizine are second generation antihistamines that are used for the treatment of allergic rhinitis, angioedema and chronic urticaria. Cetirizine and levocetirizine have been linked to rare, isolated instances of clinically apparent acute liver injury.

### Background

Cetirizine (se tir' i zeen) is a second generation antihistamine (H1 receptor blocker) that is used widely to treat allergic symptoms associated with hay fever, seasonal allergies, urticaria, angioedema and atopic dermatitis. Levocetirizine (lee" voe se tir' i zeen) is the levorotatory R-enantiomer of cetirizine and its more active form. Cetirizine and levocetirizine belong to the piperazine class of antihistamines and, like other second generation antihistamines, are considered to be nonsedating. Indeed, prospective studies have shown that sedation is less common with cetirizine and levocetirizine than with first generation antihistamines such as diphenhydramine, but some degree of sedation may still occur. Cetirizine was approved for use by prescription in the United States in 1995 and as an over-the-counter medication in 2007. Cetirizine is currently one of the most widely used medications with more than 5 million prescriptions filled yearly in addition to considerable nonprescription use. Cetirizine is available in 5 and 10 mg tablets and capsules in multiple generic forms and under the trade name Zyrtec. Oral solutions and fixed combinations with pseudoephrine are also available. The typical dose of cetirizine is 5 to 10 mg once daily and it is often given chronically, at least during allergy season. Levocetirizine was approved for use in the United States in 2007 and is currently available by prescription only. Levocetirizine is available in 5 mg tablets and in an oral solution generically and under the brand name Xyzal. Common side effects of the second generation antihistamines include blurred vision, dry mouth and throat, palpitations, tachycardia, abdominal distress, constipation and headache. Although considered to be nonsedating antihistamines, cetirizine and levocetirizine can cause mild drowsiness particularly at higher doses. Antihistamines can worsen urinary retention and glaucoma.

### Hepatotoxicity

Cetirizine and levocetirizine use are not generally associated with liver enzyme elevations, but have been linked to rare instances of clinically apparent liver injury. In published reports, the time to onset varied widely, from 1 to 40 weeks and the pattern of injury ranged from cholestatic hepatitis to hepatocellular jaundice. The reported cases were mild to moderate in severity and self-limited in course with rapid recovery after stopping the medication. Immunoallergic and autoimmune features were rare, but recurrence of acute liver injury upon reexposure to cetirizine has been described.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of acute liver injury from cetirizine is not known. It is metabolized by the liver and a toxic metabolite may account for idiosyncratic injury.

### Outcome and Management

Acute liver injury from cetirizine and levocetirizine is rare and usually self-limited. Acute liver failure and vanishing bile duct syndrome have not been linked to these second generation antihistamines. Recurrence of liver injury has been described in patients who restart cetirizine. There is no information about cross reactivity among the various antihistamines after clinically apparent hepatotoxicity, but switching to another agent with a different structure and belonging to a separate class is probably safe.

References on the safety and potential hepatotoxicity of antihistamines are given together after the Overview section on Antihistamines.

Drug Class: Antihistamines

## CASE REPORT

### Case 1. Cholestatic hepatitis caused by cetirizine.

[Modified from: Fong DG, Angulo P, Burgart LJ, Lindor KD. Cetirizine-induce cholestasis. J Clin Gastroenterol 2000; 31: 250-3. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/11034010)]

A 28 year old man developed jaundice and pruritus after having taken cetirizine (10 mg daily) for 2 years for allergic rhinitis. He had no previous history of liver disease, drug allergies, or risk factors for viral hepatitis. He drank alcohol but only on weekends, although often consuming six 12-ounce cans of beer in one sitting. His other medical conditions included only allergic rhinitis and episodes of sinusitis. His only other medications were phenylephrine nasal sprays, and he specifically denied use of other over-the-counter drugs, herbal medications or nutritional supplements. On examination, he was jaundiced but had no fever, rash, hepatomegaly or signs of chronic liver disease. Laboratory testing showed a total serum bilirubin of 9.7 mg/dL, ALT 215 U/L, AST 61 U/L, and alkaline phosphatase 260 U/L (Table). Test for viral hepatitis and autoimmune liver disease were negative. Abdominal ultrasound and endoscopic retrograde cholangiopancreatography showed no evidence of gallstones or biliary obstruction. He stopped cetirizine at the time of presentation and was treated with hydroxyzine for control of pruritus. However, jaundice and pruritus persisted, and a liver biopsy was done which showed zone 3 cholestasis and mild hepatic necrosis and inflammation compatible with drug induced liver injury. There was no steatosis or changes suggestive of alcohol related liver injury. He was started on ursodiol and improved slowly, but serum enzymes and bilirubin remained slightly elevated at the time of the last follow up visit.

#### Key Points

Medication: | Cetirizine (10 mg daily)
Pattern: | Mixed (R=2.4)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 2 years
Recovery: | Incomplete after 3 months
Other medications: | Nasal spray

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
2 years | 0 | 215 | 260 | 9.7 | Cetirizine stopped
| 1 week | 89 | 850 | 16.5 | Transfer
| 2 weeks | 77 | 825 | 22.5 | Liver biopsy
| 4 weeks | Ursodiol started
| 6 weeks | 45 | 810 | 21.0
| 8 weeks | 85 | 620 | 17.0
| 9 weeks | 180 | 480 | 9.0
| 12 weeks | 130 | 120 | 2.3 | Ursodiol stopped
Normal Values | | <45 | <251 | <1.2

*Some values estimated from Figure 2; normal values for initial Alk P were <119 U/L.

#### Comment

A young man developed severe jaundice and pruritus after taking cetirizine for allergic rhinitis for several years. He denied taking other medications and had no clinical, serologic or radiologic evidence for viral hepatitis, autoimmune liver disease or biliary tract disease. A liver biopsy showed marked cholestasis but little or no inflammation, steatosis or fibrosis. The clinical phenotype might be best described as "bland cholestasis" which raises the possibility of unacknowledged use of anabolic steroids. The prolonged jaundice and pruritus also favors this diagnosis and the cetirizine may have been used as a cover for the illicit use of body building drugs. Actually cetirizine is closely related to and metabolized to hydroxyzine (another member of the piperazine class of antihistamines), which he was given during the episode of jaundice because of pruritus. This report, like other case reports of cetirizine hepatotoxicity, is not totally convincing.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Cetirizine/Levocetirizine – Generic, Zyrtec®/Generic, Xyzal®

DRUG CLASS

Antihistamines

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Cetirizine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Cetirizine | 83881-51-0 | C21-H25-Cl-N2-O3 | Cetirizine Chemical Structure
Levocetirizine | 130018-77-8 | C21-H25-Cl-N2-O3 | Levocetirizine Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Cetirizine and Levocetirizine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Cetirizine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Cetirizine and Levocetirizine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Cetirizine)